# Trifluoperazine

## OVERVIEW

### Introduction

Trifluoperazine is a phenothiazine and antipsychotic agent that no longer commonly used in clinical practice. Trifluoperazine is a rare cause of clinically apparent acute cholestatic liver injury.

### Background

Trifluoperazine (trye" floo oh per' a zeen) is a piperazine phenothiazine derivative which acts by postsynaptic inhibition of dopamine receptors. Trifluoperazine has other peripheral and central nervous system effects, producing both alpha adrenergic stimulation and blocking histamine- and serotonin-mediated effects. Trifluoperazine is indicated for the therapy of acute and chronic psychosis and rarely for nonpsychotic anxiety. Trifluoperazine was approved for use in the United States in 1959 and was formerly a commonly prescribed antipsychotic medication, but has been replaced in recent years in large part by the atypical antipsychotics, which have fewer extrapyramidal side effects. Trifluoperazine is available as tablets of 1, 2, 5 and 10 mg in generic forms and formerly under the brand name of Stelazine. Oral solutions and parenteral formulations are also available. The typical recommended dose for nonpsychotic anxiety in adults in 1 to 2 mg twice daily, increasing as needed to a maximum of 6 mg daily. For therapy of schizophrenia the typical dose is 2 to 5 mg twice daily increasing as need to a maximum of 15 to 40 mg per day. Common side effects include drowsiness, dizziness, headache, blurred vision, dry mouth, constipation, tremor, restlessness, muscle spasms and weight gain. Uncommon but potentially severe adverse events include increased mortality in elderly patients with dementia-associated psychosis, neuroleptic malignant syndrome, tardive dyskinesia, hypotension and falls.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in a high proportion of patients on long term phenothiazine therapy, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Rare instances of clinically apparent acute liver injury, resembling that due to chlorpromazine, have been reported with trifluoperazine therapy. The onset of jaundice is usually within 1 to 4 weeks, and the pattern of serum enzyme elevations is typically cholestatic or mixed. Immunoallergic features (rash, fever and eosinophilia) were present in some cases but were mild and self-limited; autoantibodies were rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which phenothiazines cause serum aminotransferase elevations is not known. Several features of the clinical presentation of phenothiazine hepatotoxicity (short latency period, fever, eosinophilia) suggest a hypersensitivity reaction, and rechallenge typically causes a rapid recurrence of injury. Trifluoperazine is extensively metabolized by the liver via sulfoxidation and oxidation, and some instances of serum aminotransferase elevations as well as more clinical apparent liver injury may be caused by production of a toxic intermediate of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on trifluoperazine therapy are usually transient and do not require dose modification or discontinuation of therapy. The acute cholestatic hepatitis caused by trifluoperazine is typically self-limited and benign. However, a proportion of cases of phenothiazine cholestatic hepatitis may be followed by prolonged jaundice and cholestasis and vanishing bile duct syndrome. Many patients with chronic cholestasis eventually improve, but they often have persistent enzyme elevations and biliary cirrhosis. No fatalities from trifluoperazine jaundice have been reported. Rechallenge with phenothiazines usually causes a prompt recurrence of the liver injury and should be avoided. Patients with trifluoperazine induced liver injury may have cross sensitivity to other phenothiazines, but generally tolerate haloperidol and the atypical antipsychotics.

Drug Class: Antipsychotic Agents

Other Drugs in the Subclass, Phenothiazines: Chlorpromazine, Fluphenazine, Perphenazine, Prochlorperazine, Thioridazine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trifluoperazine – Generic, Stelazine®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trifluoperazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Trifluoperazine | 117-89-5 | C21-H24-F3-N3-S

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2020

Zimmerman HJ. Neuroleptic drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 483-91. (Expert review of hepatotoxicity of neuroleptic drugs including the phenothiazines published in 1999; several hundred cases of chlorpromazine jaundice have been reported due to chlorpromazine, usually cholestatic, arising after 1-5 weeks, often with fever and eosinophilia, sometimes causing vanishing bile duct syndrome; other phenothiazines have only rarely been linked to liver injury, except for prochlorperazine).
Larrey D, Ripault M-P. Phenothiazines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 452. (Review of phenothiazine hepatotoxicity mentions that liver enzyme elevations arise in up to 40% of patients taking phenothiazines and hundreds of cases of chlorpromazine jaundice have been published, frequency ~0.5-1%; onset in 2-5 weeks, usually acute cholestatic hepatitis with jaundice and pruritus; prodrome of fever and abdominal pain is common; prolonged course in 7% but usually benign; other phenothiazines have been linked to liver injury similar to that of chlorpromazine, “but with a lower frequency”).
Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Kohn N, Myerson RM. (1961). Cholestatic hepatitis associated with trifluoperazine. N Engl J Med. (48 year old man developed jaundice and abdominal pain 3 weeks after starting trifluoperazine [bilirubin 5.2 mg/dL, AST 95 U/L, Alk P ~10 x ULN, eosinophils 6%], resolving within 4 weeks of stopping).
McQueen EG. (1963). Toxic effects of phenothiazine tranquillizers. N Z Med J. (Review of the phenothiazines and their side effects: “Jaundice has occurred in about 1% of patients taking chlorpromazine, and also, although less frequently, in patients taking one of the more recently developed analogues”).
Walker CO, Combes B. (1966). Biliary cirrhosis induced by chlorpromazine. Gastroenterology. (32 year old woman and 31 year old man developed persistent jaundice [>4 years], cholestasis and liver fibrosis 3 and 4 weeks after starting chlorpromazine; acute cholestatic hepatitis evolving into chronic form with biopsies showing cirrhosis and complications of portal hypertension, most likely representing vanishing bile duct syndrome).
Margulies AI, Berris B. (1968). Jaundice associated with the administration of trifluoperazine. Can Med Assoc J. (26 year old woman developed fever, rash and pruritus 2 weeks after starting trifluoperazine [bilirubin 6.4 mg/dL, ALT 169 U/L, Alk P ~1.8 times normal, 8% eosinophils], resolving within 1 month stopping and later tolerating haloperidol without recurrence).
Ishak KG, Irey NS. (1972). Hepatic injury associated with the phenothiazines. Clinicopathologic and follow-up study of 36 patients. Arch Pathol. (Review of 36 biopsies from patients with phenothiazine induced liver injury from the files of the Armed Forces Institute of Pathology, 33 chlorpromazine, 3 prochlorperazine; mean onset 15 days after starting; eosinophilia in 73%, mean bilirubin 12.4 mg/dL, Alk P ~8 fold elevated, ALT 146 U/L; 6 [17%] had prolonged course for 10-16 months).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of drug induced liver disease seen between 1968-78 in Denmark, 51 were attributed to chlorpromazine [9%, ranking 2nd behind halothane], latency averaging 14 days [range 11-46]; 5 deaths; no other phenothiazines mentioned).
Kaplowitz N, Aw TY, Simon FR, Stolz A. (1986). Drug-induced hepatotoxicity. Ann Intern Med. (Review of drug induced hepatotoxicity including phenothiazine jaundice).
Munyon WH, Salo R, Briones DF. (1987). Cytotoxic effects of neuroleptic drugs. Psychopharmacology (Berl). (In vitro cell cytotoxicity of 8 neuroleptic drugs were compared; chlorpromazine was more toxic than haloperidol or loxapine, but similar to other phenothiazines).
Regal RE, Bili JE, Glazer HM. (1987). Phenothiazine-induced cholestatic jaundice. Clinical Pharmacy. (Review of phenothiazine induced liver injury; cross sensitivity is rare “but does exist”).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J. (Over 21 year period in New Zealand, there were 943 reports of liver injury involving 205 drugs; chlorpromazine was in the top 20 drugs implicated accounting for 2.7% of cases; prochlorperazine was cause of 4 cases, but other phenothiazines not mentioned).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics; using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kilograms).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993 and 2000, 3 were due to chlorpromazine with relative risk of 613: frequency of 261 per 100,000 person year exposures; other phenothiazines not mentioned).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were due to phenothiazines).
Flanagan RJ. (2008). Fatal toxicity of drugs used in psychiatry. Hum Psychopharmacol. (Deaths from fatal poisonings decreased in England and Wales between 1993-2004, antipsychotic overdose fatalities higher for phenothiazines than atypicals; deaths/million prescriptions being 29 for chlorpromazine, 15.5 thioridazine, 3.9 trifluoperazine, 13.3 olanzapine, 21 clozapine and 31.3 quetiapine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for phenothiazines).
Sharifi V, Amini S, Ghaeli P, Saeedinia A. (2010). Trifluoperazine-induced cholestatic jaundice. Iran J Psychiatry. (44 year old man developed jaundice 4 weeks after starting trifluoperazine [bilirubin 3.9 mg/dL, ALT 235 U/L, Alk P 744 U/L], resolving with stopping and not recurring after switching to risperidone).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to perphenazine).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review and recommendations on use of antidepressants and antipsychotic medications including phenothiazines; no discussion of hepatotoxicity).
Marwick KF, Taylor M, Walker SW. (2012). Antipsychotics and abnormal liver function tests: systematic review. Clin Neuropharmacol. (Systematic review of the literature found rates of any serum enzyme elevation during antipsychotic therapy to range from 5-78% and "clinically significant' elevations in 0-15%; lists 3 reports of clinically apparent liver injury due trifluoperazine]).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to chlorpromazine, the only antipsychotic medication listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.6%] were attributed to antipsychotic agents, including 3 due to quetiapine and 2 to olanzapine, but none to trifluoperazine or other phenothiazines]).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that the phenothiazines commonly cause sedation, postural hypotension and weight gain and often have extrapyramidal effects, but does not mention ALT elevations or hepatotoxicity).
Schreiner NM, Windham S, Barker A. (2017). Atypical neuroleptic malignant syndrome: diagnosis and proposal for an expanded treatment algorithm: a case report. A A Case Rep. (48 year old man with bipolar disorder and NASH underwent liver transplantation and developed confusion, dyskinesia, rigidity, hyperthermia and tachycardia/tachypnea postoperatively having been given lithium, lamotrigine, promethazine and ziprasidone, responding to therapy of neuroleptic malignant syndrome with benzodiazepines and propofol).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 37 taking olanzapine mean weight gain was 10.3 kg and ALT increase 2.6 U/L; increases in ALT associated with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months).

## OTHER REFERENCE LINKS

1 Recent References on Trifluoperazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Trifluoperazine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trifluoperazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trifluoperazine)